# Upadacitinib

## OVERVIEW

### Introduction

Upadacitinib is an oral selective inhibitor of Janus associated kinase 1 (JAK-1) that is used in the therapy of moderate-to-severe rheumatoid arthritis. Upadacitinib has been associated with a low rate of serum enzyme elevations during therapy, but has not been linked to cases of clinically apparent acute liver injury although it may pose a risk for reactivation of hepatitis B in susceptible patients.

### Background

Upadacitinib (ue pad” a sye’ ti nib) is an orally available, small molecule inhibitor of Janus associated kinase (JAK), which is an essential component in the signal transducer and activator of transcription (STAT) pathway of immune activation and cytokine release. Inhibition of this pathway decreases T cell activation and proinflammatory cytokine release. Upadacitinib has a relative selectivity for JAK-1 and has been shown to improve symptoms and signs of active rheumatoid and psoriatic arthritis, ankylosing spondylitis, atopic dermatitis and ulcerative colitis. Upadacitinib was approved for use in 2019 in the United States as therapy for moderate or severely active rheumatoid arthritis in patients who have failed to respond or are intolerant of conventional disease modifying antirheumatic drugs (DMARDs), such as methotrexate and hydroxychloroquine or tumor necrosis factor (TNF) blockers. Since that time, the indications for upadacitinib have been expanded to include psoriatic arthritis, ankylosing spondylitis, ulcerative colitis and atopic dermatitis. The indications are generally limited to patients with moderately to severely active disease who have failed or were intolerant to therapy with systemic treatments such as TNF blockers. Upadacitinib is available in extended release tablets of 15, 30 and 45 mg under the brand name Rinvoq. The recommended maintenance dose is 15 mg once daily. Combination with other DMARDs or biologic agents is not recommended. Recommendations are limited to adults, except for atopic dermatitis (children 12 years or older). The regimen for ulcerative colitis includes an induction phase of 45 mg once daily for 8 weeks. Common side effects include mild-to-moderate symptoms of upper respiratory infection, cough, fever, fatigue, nausea, and laboratory abnormalities of lipids, liver and muscle enzymes. Uncommon, but potentially serious side effects include serious and opportunistic infections, reactivation of latent tuberculosis, herpes zoster, venous thromboses, gastrointestinal perforation, malignancy, major cardiovascular adverse events and embryo-fetal toxicity.

### Hepatotoxicity

In the prelicensure clinical trials of upadacitinib in patients with rheumatoid arthritis, liver test abnormalities were frequent although usually mild. Some degree of ALT elevation arose in up to 11% of upadacitinib treated patients compared to 7% treated with placebo, but were above 3 times the upper limit of normal (ULN) in 2% or less. Furthermore, similar rates of ALT elevations arose in patients treated with methotrexate or biologic DMARDs. In these trials that enrolled over 3000 patients, there were no reports of clinically apparent liver injury, serious cases of liver injury or liver-related deaths. Similarly, other JAK inhibitors such as tofacitinib and baricitinib have been associated with frequent minor serum aminotransferase elevations during treatment, but episodes of clinically apparent liver injury have not been reported. Thus, this class of agents is suspected but not proven capable of causing liver injury.

In addition, long term treatment with upadacitinib and other Janus kinase inhibitors has been linked to rare instances of reactivation of hepatitis B that can be severe and has been linked to fatal outcomes. Reactivation can become clinically apparent after the JAK inhibitor is discontinued, when immune restoration results in an immunologic response to the heightened viral replication.

Likelihood score: D (possible, rare cause of clinically apparent liver injury including reactivation of hepatitis B in susceptible patients).

### Mechanism of Injury

The cause of liver injury from upadacitinib is unknown, but with pattern of abnormalities suggests some degree of low level, direct hepatotoxicity. Thus, mean ALT levels rise slightly during the first 4 to 8 weeks of therapy (by approximately 5 U/L and usually remaining within the normal range) and return to baseline rapidly with stopping. In instances of more marked elevations, the abnormalities also resolve rapidly with discontinuation and may not recur with reexposure. Upadacitinib is metabolized in the liver via the cytochrome P450 system, largely CYP 3A4 (and by CYP 2D6 to a lesser extent) and is susceptible to drug-drug interactions with agents that inhibit or induce the CYP enzyme reactivity.

Reactivation of hepatitis B from JAK inhibitors, in contrast, is likely due to indirect effects of upadacitinib in causing immune suppression which may to lead to increased HBV replication which if followed by immune recovery, can result in acute liver injury.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary cessation. In patients with clinically apparent liver injury and jaundice, restarting therapy should be done with caution. Cross sensitivity to liver injury is uncommon among the tyrosine kinase inhibitors but there is no information or shared adverse event sensitivity among the small molecule JAK inhibitors. Tofacitinib and baricitinib have been linked to cases of reactivation of hepatitis B which can be severe. Importantly, patients who are to receive long term therapy with upadacitinib should be screened for hepatitis B (HBsAg and anti-HBc). Patients with HBsAg in serum should be treated prophylactically with an oral antiviral agent with activity against HBV such as entecavir or tenofovir. An alternative, which is applicable to those with anti-HBc without HBsAg, is to monitor patients carefully for HBV DNA levels to detect evidence of reactivation early and initiate appropriate therapy for HBV infection.

Drug Class: Antirheumatic Agents, Protein Kinase Inhibitors

Other Drugs in the Subclass, Janus Kinase Inhibitors for Rheumatoid Arthritis: Baricitinib, Tofacitinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Upadacitinib – Rinvoq®

DRUG CLASS

Antirheumatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Upadacitinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Upadacitinib | 1310726-60-3 | C17-H19-F3-N6-O

## ANNOTATED BIBLIOGRAPHY

References updated: 30 August 2022

Abbreviations: DMARDs, disease modifying antirheumatic drugs; HBV, hepatitis B virus; JAK, Janus associated kinase; TNF, tumor necrosis factor.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents, does not discuss upadacitinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/211675Orig1s000MedR.pdf (FDA website with product labels and initial clinical review of the safety and efficacy of upadacitinib; states that upadacitinib recipients in a higher rate of ALT elevations than those on placebo [11.4% vs 7.2%] but rates were similar or lower in comparison to other disease modifying antirheumatic drugs [DMARDs], few episodes of aminotransferase elevations resulted in discontinuation, and no cases of liver injury with jaundice were reported, although one subject developed acute hepatitis B reactivation [ALT 1556 U/L, bilirubin 13.1 mg/dL, no information on HBV markers or outcome]).
Burmester GR, Kremer JM, Van den Bosch F, Kivitz A, Bessette L, Li Y, Zhou Y, et al. (2018). Safety and efficacy of upadacitinib in patients with rheumatoid arthritis and inadequate response to conventional synthetic disease-modifying anti-rheumatic drugs (SELECT-NEXT): a randomised, double-blind, placebo-controlled phase 3 trial. Lancet. (Among 661 adults with rheumatoid arthritis refractory to conventional DMARDs treated with upadacitinib [15 or 30 mg] or placebo daily for 12 weeks, response rates were higher with upadacitinib [64% and 66% vs 36%] while adverse events were slightly more frequent [57% and 54% vs 49%], although rates of “hepatic disorders” were similar in all 3 groups [2% and 3% vs 2%] and ALT elevations above 3 times ULN were rare [none and 0.9% vs 1.9%]).
Bechman K, Subesinghe S, Norton S, Atzeni F, Galli M, Cope AP, Winthrop KL, et al. (2019). A systematic review and meta-analysis of infection risk with small molecule JAK inhibitors in rheumatoid arthritis. Rheumatology (Oxford). (Systematic review of controlled trials of JAK inhibitors for rheumatoid arthritis for serious infections identified 21 studies, providing rates per 100 patient-years of exposure for serious infections as 1.97 for tofacitinib, 3.16 baricitinib, and 3.02 upadacitinib vs 2.50 for placebo and for herpes zoster as 2.51 for tofacitinib, 3.16 baricitinib, 2.41 and upadacitinib vs 1.22 for placebo; no mention of HBV reactivation).
Duggan S, Keam SJ. (2019). Upadacitinib: first approval. Drugs. (Review of the history of development, mechanism of action, pharmacokinetics, clinical efficacy, and safety in rheumatoid arthritis, as well as psoriatic arthritis, Crohn disease, ulcerative colitis, and atopic dermatitis, shortly after its approval for use in the United States; no mention of hepatotoxicity or ALT elevations).
(2019). Upadacitinib (Rinvoq) - a new JAK inhibitor for rheumatoid arthritis. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of upadacitinib shortly after its approval for use in rheumatoid arthritis in the US; no mention of hepatotoxicity or ALT elevations).
van der Heijde D, Song IH, Pangan AL, Deodhar A, van den Bosch F, Maksymowych WP, Kim TH, et al. (2019). Efficacy and safety of upadacitinib in patients with active ankylosing spondylitis (SELECT-AXIS 1): a multicentre, randomised, double-blind, placebo-controlled, phase 2/3 trial. Lancet. (Among 187 adults with ankylosing spondylitis treated with upadacitinib vs placebo for 14 weeks, response rates were 52% vs 26% while adverse events were more frequent with upadacitinib [62% vs 55%], and while there were no serious infections or venous thrombosis, CPK elevations arose in 9% vs 2% and “hepatic disorders” in 5% vs 2%, but the ALT elevations were all asymptomatic, below 3 times ULN and transient, none requiring drug discontinuation).
(2019). Drugs for psoriatic arthritis. Med Lett Drugs Ther. (Concise review of the mechanism of action, relative clinical efficacy, safety and costs of drugs approved for use in psoriatic arthritis including NSAIDS, methotrexate, sulfasalazine, leflunomide, cyclosporine, apremilast, TNF inhibitors, ustekinumab, secukinumab, ixekizumab, abatacept, and the Jak inhibitor, tofacitinib; upadacitinib had been studied but had yet to be approved for this indication).
van Vollenhoven R, Takeuchi T, Pangan AL, Friedman A, Mohamed MF, Chen S, Rischmueller M, et al. (2020). Efficacy and safety of upadacitinib monotherapy in methotrexate-naive patients with moderately-to-severely active rheumatoid arthritis (SELECT-EARLY): a multicenter, multi-country, randomized, double-blind, active comparator-controlled trial. Arthritis Rheumatol. (Among 947 adults with rheumatoid arthritis and no or limited exposure to methotrexate treated with upadacitinib [15 or 30 mg daily] vs methotrexate [5-20 mg/kg weekly], response rates at 24 weeks were 48% and 50% vs 19% while adverse event rates were 64% and 71% vs 65%, and rates of “hepatic disorders” were equal across groups [6.0% and 4.5% vs 4.4%], while ALT elevations above 3 times ULN were more frequent with methotrexate [1.8% and 1.6% vs 4.4%]).
Rubbert-Roth A, Enejosa J, Pangan AL, Haraoui B, Rischmueller M, Khan N, Zhang Y, et al. (2020). Trial of upadacitinib or abatacept in rheumatoid arthritis. N Engl J Med. (Among 612 adults with rheumatoid arthritis refractory to DMARDs treated with upadacitinib vs abatacept for 24 weeks, upadacitinib was associated with greater decrease in symptom scores (-2.5 vs -2.0), higher rate of remission [30% vs 13%], but also higher rates of adverse events [69% vs 61%], serious adverse events [3.3% vs 1.6%], and ALT elevations above 5 times ULN [2.5% vs none], although none of the ALT elevations were accompanied by jaundice).
Cohen SB, van Vollenhoven RF, Winthrop KL, Zerbini CAF, Tanaka Y, Bessette L, Zhang Y, et al. (2021). Safety profile of upadacitinib in rheumatoid arthritis: integrated analysis from the SELECT phase III clinical programme. Ann Rheum Dis. (Analysis of adverse events reported in 5 large clinical trials of upadacitinib for rheumatoid arthritis found that serious infections, herpes zoster, CPK elevations and gastrointestinal perforations were more frequent with upadacitinib than methotrexate while venous thromboses, malignancies, cardiovascular events, death and rates of ALT abnormalities were not more frequent).
McInnes IB, Anderson JK, Magrey M, Merola JF, Liu Y, Kishimoto M, Jeka S, et al. (2021). Trial of upadacitinib and adalimumab for psoriatic arthritis. N Engl J Med. (Among 1704 adults with psoriatic arthritis refractory to conventional DMARDs therapy treated with upadacitinib [15 or 30 mg daily], placebo or adalimumab for 24 weeks, improvement in symptom scores was greater with upadacitinib [71% and 79% vs 36% with placebo and 65% adalimumab], while adverse event included similar rates of ALT elevations above 5 times ULN [0.9% and 1.2% vs 1.7% and 0.9%] and no patient developed ALT elevations accompanied by jaundice).
Mysler E, Lizarraga A. (2021). Phase III trials of JAK1 selective inhibitors in rheumatoid arthritis. Rheumatology (Oxford). (Review of efficacy results from 6 controlled trials of upadacitinib and 4 of filgotinib both of which are JAK-1 selective inhibitors reported 12-48 week response rates of 52-71% with upadacitinib vs 28-36% with placebo, and intermediate rates with methotrexate and adalimumab; no discussion of aminotransferase elevations or hepatotoxicity).
Clarke B, Yates M, Adas M, Bechman K, Galloway J. (2021). The safety of JAK-1 inhibitors. Rheumatology (Oxford). (Review of the selective side effects of the JAK-1 inhibitors focusing upon infections [serious and non-serious and opportunistic including herpes zoster], venous thromboses, malignancy, blood disorders, changes in lipid levels, muscle enzymes, and hepatotoxicity states that elevations of aminotransferase levels occurs equally with JAK inhibitors, methotrexate and other biologic DMARDs and that no cases of ALT elevations with jaundice have been reported in the pre-registration clinical trials).
Mease PJ, Lertratanakul A, Papp KA, van den Bosch FE, Tsuji S, Dokoupilova E, Keiserman MW, et al. (2021). Upadacitinib in patients with psoriatic arthritis and inadequate response to biologics: 56-week data from the randomized controlled phase 3 SELECT-PsA 2 Study. Rheumatol Ther. (Among 641 adults with refractory psoriatic arthritis treated with upadacitinib [15 or 30 mg daily] or placebo for 24 weeks followed by upadacitinib in all for up to 56 weeks, response rates were similar with the two doses [60% and 59% at 56 weeks, vs ~20% at 24 weeks for placebo] while adverse events were slightly less common with the 15 mg dose, serious events in 14% vs 16%, herpes zoster in 4% vs 9%, “hepatic disorders” in 5% vs 18% although ALT elevations above 3 times ULN occurred in only 1% with both doses and no patient developed ALT elevations with jaundice).
Guttman-Yassky E, Teixeira HD, Simpson EL, Papp KA, Pangan AL, Blauvelt A, Thaçi D, et al. (2021). Once-daily upadacitinib versus placebo in adolescents and adults with moderate-to-severe atopic dermatitis (Measure Up 1 and Measure Up 2): results from two replicate double-blind, randomised controlled phase 3 trials. Lancet. (Combined results of two large trials in a total of 1683 adolescents and adults with atopic dermatitis treated with upadacitinib [15 or 30 mg] or placebo for 16 weeks, found higher rates of response with upadacitinib [71% vs 15%] and slightly higher rate of total adverse events [64% vs 56%], but similar low rates of severe adverse events [2.3% vs 2.8%] and of “hepatic disorders” [1.6% vs 1.0%] with no instances of clinically apparent liver injury with jaundice).
Reich K, Teixeira HD, de Bruin-Weller M, Bieber T, Soong W, Kabashima K, Werfel T, et al. (2021). Safety and efficacy of upadacitinib in combination with topical corticosteroids in adolescents and adults with moderate-to-severe atopic dermatitis (AD Up): results from a randomised, double-blind, placebo-controlled, phase 3 trial. Lancet. (Among 901 adolescents and adults with chronic atopic dermatitis treated with upadacitinib [15 or 30 mg] or placebo daily for 16 weeks, response rates were higher with upadacitinib [65% and 77% vs 26%] as were total adverse events [67% and 72% vs 63%], while severe adverse event rates were similar [1% and 1% vs s%], as were “hepatic disorders” [2% and 1% vs 2%] which were mostly transient, mild ALT elevations without symptoms or jaundice).
Blauvelt A, Teixeira HD, Simpson EL, Costanzo A, De Bruin-Weller M, Barbarot S, Prajapati VH, et al. (2021). Efficacy and safety of upadacitinib vs dupilumab in adults with moderate-to-severe atopic dermatitis: A randomized clinical trial. JAMA Dermatol. (Among 692 adults with atopic dermatitis treated for 24 weeks with upadacitinib [30 mg daily] or dupilumab [300 mg by injection every other week], response rates were higher with upadacitinib [71% vs 61%], but so were total adverse events [73% vs 63%], serious adverse events [2.9% vs 1.2%], and “hepatic disorders” [2.9% vs 1.2%] which were mostly transient, mild-to-moderate ALT elevations, although 2 patients on upadacitinib discontinued therapy early because of them).
(2021). Drugs for rheumatoid arthritis. Med Lett Drugs Ther. (Concise summary of the mechanism of action, clinical efficacy, toxicity and costs of drugs used to treat rheumatoid arthritis including baricitinib, tofacitinib and upadacitinib, common adverse events of which are gastrointestinal symptoms, nasopharyngitis and headache, while aminotransferase elevations can occur as well as dyslipidemia and cytopenias; rare adverse events may include major adverse cardiovascular events, thrombosis, malignancy and increase risk of death).
Song YK, Song J, Kim K, Kwon JW. (2022). Potential adverse events reported with the Janus Kinase inhibitors approved for the treatment of rheumatoid arthritis using spontaneous reports and online patient reviews. Front Pharmacol. (Analysis of spontaneous adverse event reports to the US and Korean Adverse Event Reporting Systems between 2013 and 2020 identified 21,708 reports on JAK inhibitors, predominantly tofacitinib [92], of which less than 1% were hepatobiliary).
Burmester GR, Winthrop K, Blanco R, Nash P, Goupille P, Azevedo VF, Salvarani C, et al. (2022). Safety profile of upadacitinib up to 3 years in psoriatic arthritis: an integrated analysis of two pivotal phase 3 trials. Rheumatol Ther. (Pooled analysis of 2 controlled trials in patients with psoriatic arthritis treated with upadacitinib [15 or 30 mg once daily for up to 3 years], adalimumab [40 mg every other week] or placebo [for 6 months] found rates of adverse events similar in the four groups but higher rates of herpes zoster and CPK elevations with upadacitinib; ALT elevations above 5 times ULN arose in 1.3% on placebo, 1.9% on adalimumab and 1.2% and 1.7% on upadacitinib and no patient developed clinically apparent liver injury with jaundice).
Danese S, Vermeire S, Zhou W, Pangan AL, Siffledeen J, Greenbloom S, Hébuterne X, et al. (2022). Upadacitinib as induction and maintenance therapy for moderately to severely active ulcerative colitis: results from three phase 3, multicentre, double-blind, randomised trials. Lancet. (Among 451 patients with ulcerative colitis who responded to an induction phase of upadacitinib [45 mg daily for 8 weeks] who were then treated with upadacitinib [15 or 30 mg] or placebo once daily for 52 weeks, no patient developed ALT elevations above 3 times upper limit or normal or required discontinuation of therapy because of hepatic events).
van der Heijde D, Baraliakos X, Sieper J, Deodhar A, Inman RD, Kameda H, Zeng X, et al. Efficacy and safety of upadacitinib for active ankylosing spondylitis refractory to biological therapy: a double-blind, randomised, placebo-controlled phase 3 trial. Ann Rheum Dis. 2022:annrheumdis-2022-222608. (Among 420 patients with ankylosing spondylitis treated with upadacitinib [15 mg] or placebo once daily for 14 weeks, response rates were higher with upadacitinib [45% vs 18%] as were adverse events [41% vs 37%], serious adverse events [2.8% vs 0.5%], serious infections [2.4% vs none] and ALT elevations [2.8% vs 1%] but there were no cases of clinically apparent liver injury with jaundice).
Deodhar A, Van den Bosch F, Poddubnyy D, Maksymowych WP, van der Heijde D, Kim TH, Kishimoto M, et al. (2022). Upadacitinib for the treatment of active non-radiographic axial spondyloarthritis (SELECT-AXIS 2): a randomised, double-blind, placebo-controlled, phase 3 trial. Lancet. (Among 314 patients with active axial spondyloarthritis treated with upadacitinib [15 mg] or placebo once daily for 14 weeks, response rates were higher with upadacitinib [45% vs 23%] while adverse event rates were similar [48% vs 46%], including aminotransferase elevations [3% in both groups] and there were no cases of clinically apparent liver injury with jaundice).
(2022). Upadacitinib (Rinvoq): a second JAK inhibitor for ulcerative colitis. Med Lett Drugs Ther. (Concise summary of the mechanism of action, clinical efficacy, toxicity and costs of upadacitinib for ulcerative colitis, the second JAK inhibitor approved for this indication [the first being tofacitinib], mentions that it has been reported to cause liver enzyme elevations and rash).

## OTHER REFERENCE LINKS

1 Recent References on Upadacitinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Upadacitinib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Upadacitinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Upadacitinib)